# Protease Inhibitors (HCV)

## OVERVIEW

### Introduction

The hepatitis C virus (HCV) specific protease inhibitors are a class of agents that block the enzymatic activity of the HCV NS3 protease region that is necessary for protein processing required for viral replication. The combination of an HCV protease inhibitor with other antiviral agents with activity against HCV (such as peginterferon, ribavirin, and the direct acting agents that block the NS5A and NS5B regions of the virus) leads to marked decrease in HCV replication and eradication of the infection in a high proportion of patients with chronic hepatitis C. At least four HCV protease inhibitors have been approved for use in the United States (boceprevir, glecaprevir, grazoprevir, paritaprevir, simeprevir, telaprevir), and others were evaluated in clinical studies (asunaprevir, danoprevir, faldaprevir, sovaprevir, vedroprevir). The HCV protease inhibitors are approved for use only in combination with other specified anti-HCV agents. The initially approved protease inhibitors had activity only against HCV genotype 1, the most common genotype strain found in the United States and most of the world. Currently approved agents, in contrast, have broad specificity against multiple HCV genotypes.

### Background

The hepatitis C virus is a small RNA virus that is a major cause of acute and chronic hepatitis in the United States as well as worldwide. A striking feature of HCV infection is that the majority of affected persons (50% to 70%) develop chronic infection, which can lead to chronic liver injury, cirrhosis, end stage liver disease and hepatocellular carcinoma. An estimated 3.2 million Americans (~1.2%) are chronically infected with HCV, and up to one-third of them will develop cirrhosis or liver cancer as a result of this virus infection. Various approaches to antiviral therapy of chronic hepatitis C have been developed, starting in the 1980s with interferon alfa, which was replaced in the 1990s by long acting pegylated forms of interferon (peginterferon) to which was added the oral nucleoside analogue, ribavirin. Between 2010 and 2015, several potent direct acting anti-HCV agents were developed and combinations of these were found to have marked activity against the virus. When given in combination for 8, 12 or 24 weeks, these regimens can result in eradication of the viral infection and cure of the liver disease in 90% to 100% of patients without the need for peginterferon. These oral direct acting agents target various components of HCV, most commonly the NS3 region (viral protease) and the NS5 region (viral polymerase), which includes a structural region (NS5A) and the active polymerase enzyme region (NS5B).

The HCV protease inhibitors block the activity of the viral encoded protease that is essential in the post-translational modification of the viral polypeptide that is cleaved into a series of structural and nonstructural (enzyme) regions. The HCV proteases that have been developed are polypeptide-like molecules, modified amino acids that act as competitive inhibitors of the viral serine protease, resembling the specific amino acid sequence that the protease cleaves. At least seven HCV protease inhibitors (-previrs) have been approved for use in the United States (boceprevir [2012], telaprevir [2012], simeprevir [2013], paritaprevir [2014]) and grazoprevir [2015], and several more are in various stages of preclinical and clinical development.

The HCV protease inhibitors are generally well tolerated, but common adverse events include headache, dizziness, nausea, diarrhea, abdominal discomfort and rash. Liver injury has been reported with several of the HCV protease inhibitors, particularly asunaprevir which has been linked to acute hepatitis with immunoallergic features, sometimes as a part of a generalized hypersensitivity reaction. The onset of injury was within 4 to 12 weeks and was usually accompanied by fever, rash and eosinophilia. Serum enzyme elevations are typically hepatocellular and jaundice is mild-to-moderate in severity. At least one fatal instance of liver injury has been reported with asunaprevir. While asunaprevir has generally been given in combination with daclatasvir and sometimes with ribavirin, the liver injury has convincingly been attributed to asunaprevir in most cases.

The eight HCV protease inhibitors described in LiverTox are listed below with specific links. Many of these have been voluntarily discontinued by the sponsor because of the availability of more effective and better tolerated regimens of oral direct acting agents for hepatitis C. Three of the withdrawn agents are discussed separately including boceprevir, simeprevir and telaprevir, as they were available individually and were generally combined with other available agents with activity against HCV. Paritaprevir is discussed only in relation to the other antiviral agents with which it was combined, either in the product known as Viekira Pak (dasabuvir, ombitasvir and raritaprevir with ritonavir: D-O-P/r) or as Technive (ombitasvir and paritaprevir with ritonavir: O-P/r) both of which were withdrawn in 2018. Grazoprevir is discussed only in relation to elbasvir with which it is combined in a product known as Zepatier. Glecaprevir is discussed only in relation to pibrentasvir with which it is combined in a product known as Mavyret.

HCV Protease Inhibitors

- Asunaprevir [approved in some countries but never in the US, subsequently withdrawn]
- Boceprevir [approved in the US in 2012, withdrawn 2015]
- Glecaprevir: Mavyret [approved in the US in 2017]
- Grazoprevir: Zepatier [approved in the US in 2016]
- Paritaprevir: Technive, Viekira Pak [approved in the US in 2015, withdrawn 2018]
- Simeprevir [approved in the US in 2013, withdrawn 2018]
- Telaprevir [approved in the US in 2012, withdrawn 2015]
- Voxilaprevir: Vosevi [approved in the US in 2017]

Drug Class: Antiviral Agents, Hepatitis C Agents

## ANNOTATED BIBLIOGRAPHY

References updated: 25 January 2022

Kim JL, Morgenstern KA, Lin C, Fox T, Dwyer MD, Landro JA, Chambers SP, et al. (1996). Crystal structure of the hepatitis C virus NS3 protease domain complexed with a synthetic NS4A cofactor peptide. Cell. (Report of the crystal structure of the NS3/4 region of HCV with detailed description of the active serine protease catalytic site, the target for subsequent development of specific inhibitors of the HCV protease).
(2011). Telaprevir (Incivek) and boceprevir (Victrelis) for chronic hepatitis C. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of boceprevir and telaprevir shortly after their approval for use as a part of triple therapy of chronic hepatitis C, genotype 1, in the US, mentions side effects of rash, anemia, fatigue, pruritus, nausea and anorectal pruritus and burning, but not ALT elevations or clinically apparent liver injury).
Rosenquist Å, Samuelsson B, Johansson PO, Cummings MD, Lenz O, Raboisson P, Simmen K, et al. (2014). Discovery and development of simeprevir (TMC435), a HCV NS3/4A protease inhibitor. J Med Chem. (Summary of the development of protease inhibitors for treatment of chronic hepatitis C including simeprevir [TMC435], a novel cyclopentane macrocyclic inhibitor identified by screening in HCV NS3 protease assays, application of structure based design and validation in HCV replicon systems).
Schinazi R, Halfon P, Marcellin P, Asselah T. (2014). HCV direct-acting antiviral agents: the best interferon-free combinations. Liver Int. (Summary of safety and efficacy of various all-oral regimens for therapy of hepatitis C; does not discuss hepatic decompensation, hepatotoxicity or ALT elevations during therapy).
(2014). Simeprevir (Olysio) for chronic hepatitis C. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of simeprevir shortly after its approval in the US as a part of combination therapy of chronic hepatitis C, genotype 1, mentions side effects of rash, photosensitivity, pruritus, nausea, fatigue and dyspnea; simeprevir can cause serum bilirubin elevations, but these are generally mild, transient and in the indirect(unconjugated) fraction and are not associated with ALT elevations or other evidence of liver injury).
(2015). A 4-drug combination (Viekira Pak) for hepatitis C. Med Lett Drugs Ther. (Concise summary of clinical efficacy, side effects, drug-drug interactions and costs of Viekira Pak [D-O-P/r] for chronic hepatitis C, genotype 1, shortly after its approval in the US, mentions that ALT elevations occur in 1-4% of patients and may require early discontinuation, for which reason ALT monitoring is recommended for the first 4 weeks).
Pawlotsky JM, Feld JJ, Zeuzem S, Hoofnagle JH. (2015). From non-A, non-B hepatitis to hepatitis C virus cure. J Hepatol. (History of the development of therapy for chronic hepatitis C starting with the discovery of a third form of viral hepatitis, through early days of use of interferon alfa, the addition of ribavirin and development of peginterferon, concluding with the arrival of oral direct acting antiviral agents which in combination yielded response rates of more than 95%, with well tolerated regimens of 8 or 12 weeks).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
(2016). Elbasvir/grazoprevir (Zepatier) for hepatitis C. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, side effects and costs of the fixed combination of elbasvir and grazoprevir known as Zepatier, shortly after its approval for use in the US, mentions minor side effects of fatigue, headache and nausea and that ALT elevations occurred in 1% of treated patients and that the agent is contraindicated in patients with cirrhosis).
(2017). Mavyret and Vosevi--two new combinations for chronic HCV infection. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, side effects and costs of the fixed combination of glecaprevir and pibrentasvir known as Mavyret and the triple fixed combination of sofosbuvir, velpatasvir and voxilaprevir known as Vosevi, shortly after their approval for use in the US, mentions that all combination regimens for hepatitis C have a boxed warning about the possibility of causing reactivation of hepatitis B).